# Grape Seed

## OVERVIEW

### Introduction

Grape seed extracts are purported to have antioxidant, cardioprotective, antiinflammatory, and antineoplastic effects and are promoted as being helpful for general wellness as well as for diverse metabolic, vascular, heart, urinary tract, skin, and eye conditions. Extracts of grape seeds, fruit and leaves, as well as juices made from grapes, have not been associated with serum enzyme elevations during therapy nor have they been implicated in cases of clinically apparent acute liver injury.

### Background

Extracts made from grape seeds, leaves or fruit as well as grape juice have antioxidant activity and have been purported to be beneficial for health and preventing complications of stress and aging. Grapes (Vitis vinifera) are probably native to southern Europe and western Asia, but now comprise multiple subspecies that are grown in temperate regions throughout the world. The major uses of grapes are as edible fruit and as liquid in juices and wines. Grape horticulture is a major agricultural industry and the products a major component of human consumption. Drinking moderate amounts of wine is purported to have health benefits including cardioprotective activity, decreasing the risk of coronary artery disease. These claims are based upon observational and correlational studies and not prospective, randomized, placebo controlled trials. Drinking more than modest amounts of wine and alcohol on a regular basis is clearly associated with many social problems, health risks and shortened survival, and recent evidence suggests that even modest amounts of alcohol consumption is associated with health risks.

The seeds and leaves of grapes have multiple components with antioxidant and other possible beneficial activities and are available as extracts in multiple forms and concentrations alone or in combination with other herbal extracts, vitamins, minerals, and nutritional supplements in concentrations of 25 to 500 mg. Grape seed extracts are rich in proanthocyanidin which has antioxidant activity in vitro and has been purported to be beneficial for many conditions, including systemic arterial hypertension, hypercholesterolemia, coronary artery disease, edema, peripheral venous insufficiency, breast induration, pancreatitis, and vision problems. None of these claims, however, has been verified in properly designed and adequately powered prospective studies, and grape seed extracts have not been approved for any medical condition in the United States by the FDA. On the other hand, grape seed, leaf and fruit extracts are well tolerated with no or minimal side effects. Adverse events reported in clinical trials have included mild degrees of itchy skin, dizziness, headache, and nausea but a similar incidence of these adverse events was often found in patients receiving placebos.

### Hepatotoxicity

In multiple, largely short term clinical studies of different preparations and concentrations of grape seed extracts, adverse side effects were usually described as uncommon and minimal with no mention of either hepatotoxicity or ALT elevations. Few prospective studies have included regular monitoring of liver tests, but those that did reported no change in serum aminotransferase levels, and if anything, a slight decrease in alkaline phosphatase values. Despite widespread use, there have been no published reports of serum enzyme elevations or clinically apparent liver injury attributable to grape extracts.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which grape seed extracts might cause liver injury is unknown. Extracts of grape seed generally have moderately high levels of polyphenols but low levels of the polyphenolic catechins that are found in high levels in green tea (Camellia sinensis).

### Outcome and Management

Hepatotoxicity from extracts of grape seed, leaves or fruit has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Proanthocyanidin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Grape Seed – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/grape-seed-extract)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Grape Seed | 84929-27-1 (https://pubchem.ncbi.nlm.nih.gov/compound/78577443) | Herbal | Not Applicable
Proanthocyanidin | 18206-61-6 | C31-H28-O12

## ANNOTATED BIBLIOGRAPHY

References updated: 20 March 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not grape seed extract).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of grape products).
Grape. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 405-410. (Compilation of short monographs on herbal medications and dietary supplements).
Banerjee B, Bagchi D. (2001). Beneficial effects of a novel IH636 grape seed proanthocyanidin extract in the treatment of chronic pancreatitis. Digestion. (Three patients with persistent pancreatitis and pain despite conventional therapies were treated with grape seed extract [100 mg three times daily] and had marked improvement in pain within 1-2 weeks; no mention of adverse events, ALT levels or hepatotoxicity).
Vogels N, Nijs IM, Westerterp-Plantenga MS. (2004). The effect of grape-seed extract on 24 h energy intake in humans. Eur J Clin Nutr. (Among 51 subjects treated with grape seed extract or placebo for 3 days while undergoing extensive evaluation of energy intake and expenditure, there were no differences in energy requirements between the two groups; no mention of tolerance, adverse events, ALT levels or hepatotoxicity).
Brooker S, Martin S, Pearson A, Bagchi D, Earl J, Gothard L, Hall E, et al. (2006). Double-blind, placebo-controlled, randomised phase II trial of IH636 grape seed proanthocyanidin extract (GSPE) in patients with radiation-induced breast induration. Radiother Oncol. (Among 68 women with breast induration after radiation for breast cancer who were treated with grape seed extract [100 mg thrice daily] or placebo for 6 months, there were no differences in reduction of the area of induration or in discomfort or appearance between the grape seed extract and placebo treated groups; no mention of tolerance, adverse events, ALT levels or hepatotoxicity).
Mellen PB, Daniel KR, Brosnihan KB, Hansen KJ, Herrington DM. (2010). Effect of muscadine grape seed supplementation on vascular function in subjects with or at risk for cardiovascular disease: a randomized crossover trial. J Am Coll Nutr. (Among 50 patients with high risk for coronary artery disease treated with grape seed extract [650 mg twice daily] or placebo for 4 weeks in a crossover trial, there were no differences in changes of brachial flow mediated vasodilation, blood pressure, cholesterol [total, LDL and HDL], fasting blood glucose, hemoglobin A1c, C-reactive protein or IL-6 levels during grape seed extract vs placebo periods of therapy; no mention of adverse events, ALT levels or hepatotoxicity).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list grape seed extract among products associated with 5 or more reports).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not grape seed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but does not mention or list grape seed extract).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention grape seed extract).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Sano A, Tokutake S, Seo A. (2013). Proanthocyanidin-rich grape seed extract reduces leg swelling in healthy women during prolonged sitting. J Sci Food Agric. (Among 8 sedentary Japanese adults given grape seed extract or placebo in a single dose of 400 mg and another 8 subjects given 133 mg of grape seed extract for 14 days, complaints of leg swelling increased in both placebo and grape seed treated groups and there were no changes in total body water or in other symptoms, and no abnormal biochemical tests in either group).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to grape seed extract).
Martinez-Zapata MJ, Vernooij RW, Uriona Tuma SM, Stein AT, Moreno RM, Vargas E, Capellà D, et al. (2016). Phlebotonics for venous insufficiency. Cochrane Database Syst Rev. (Cochrane review of the efficacy of various herbal preparations for venous insufficiency included only one trial of grape seed extract which demonstrated a marginal effect; no mention of adverse events, ALT elevations or hepatotoxicity).
Park E, Edirisinghe I, Choy YY, Waterhouse A, Burton-Freeman B. (2016). Effects of grape seed extract beverage on blood pressure and metabolic indices in individuals with pre-hypertension: a randomised, double-blinded, two-arm, parallel, placebo-controlled trial. Br J Nutr. (Among 36 adults with “pre-hypertension” treated with grape seed extract [150 mg twice daily] or placebo for 6 weeks, there were minor changes in systolic blood pressure and “no adverse events related to treatment were reported during the study”; no mention of ALT elevations or hepatotoxicity).
Sano A. (2017). Safety assessment of 4-week oral intake of proanthocyanidin-rich grape seed extract in healthy subjects. Food Chem Toxicol. (Among 29 healthy Japanese volunteers treated with grape seed extract for 4 weeks in doses of 1000, 1500 or 2500 mg daily, mild symptoms of headache, nausea, constipation and diarrhea occurred in a few patients, but there were no changes in routine biochemical tests including ALT, AST, GGT, Alk P and bilirubin).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss grape seed).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of grape seed).
Asbaghi O, Nazarian B, Reiner Ž, Amirani E, Kolahdooz F, Chamani M, Asemi Z. (2020). The effects of grape seed extract on glycemic control, serum lipoproteins, inflammation, and body weight: a systematic review and meta-analysis of randomized controlled trials. Phytother Res. (A metaanalysis of clinical trials of grape seed extract vs placebo for effects on glycemic control, lipoproteins, inflammation and body weight identified minor average decreases in fasting blood glucose [-2 mg/dL], cholesterol [-6 mg/dL], triglycerides [-6.5 mg/dL] and C reactive protein [-0.8 mg/L], but no change in hemoglobin A1c levels or body weight; no mention of tolerance or adverse events).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; grape seed nut was not listed among the 79 implicated products).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while grape seed is not mentioned).
Zamani M, Ashtary-Larky D, Hafizi N, Naeini F, Rezaei Kelishadi M, Clark CCT, Davoodi SH, et al. (2022). The effect of grape products on liver enzymes: a systematic review and meta-analysis of randomized controlled trials. Phytother Res. (Systematic review identified 11 controlled trials of grape seed extract in which serum enzymes were assessed before and at the end of therapy; changes in ALT and AST did not differ between active drug and placebo [-1.9 U/L for ALT, and -1.1 U/L for AST], while alkaline phosphatase levels did decrease slightly more with grape seed extract compared to placebo [-5 U/L]).

## OTHER REFERENCE LINKS

1 Recent References on Grape Seed Extract: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Grape+Seed+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Stinging Grape Seed Extract: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Grape%20Seed)